# Glucagon-Like Peptide-1 (GLP-1) Analogues

## OVERVIEW

Glucagon-like peptide-1 (GLP-1) is an incretin, a gastrointestinal polypeptide hormone that binds to specific receptors on pancreatic beta cells and increases insulin release. The incretins – GLP-1 and gastric inhibitory peptide (GIP) – are secreted from the upper gastrointestinal tract in response to feeding and act on the pancreas, increasing insulin release even before blood glucose levels are elevated. The incretins also delay gastric emptying and suppress glucagon secretion, features that may increase their beneficial effects in type 2 diabetes. Both hormones are polypeptides that are rapidly cleared from the serum by the peptide cleaving enzyme, dipeptidyl peptidase-4 (DPP-4). The incretin pathway provides several potential targets for therapy of type 2 diabetes, the main ones being DPP-4 (inhibition) and GLP-1 receptors (agonist activity). Several GLP-1 analogues (also called GLP-1 receptor agonists) have been developed and approved for use in the United States for type 2 diabetes: exenatide (also known as exendin-4, Byetta) in 2005, liraglutide (Victoza) in 2010, albiglutide (Tanzeum) and dulaglutide (Trulicity) in 2014, lixisenatide (Adlyxin) in 2016 and semaglutide (Ozempic) in 2018. All are given parenterally and are approved for use in type 2 diabetes only. The GLP-1 analogues are recombinant polypeptides, have little or no hepatic metabolism and have not been convincingly implicated in causing clinically apparent liver injury.

Selected references to the safety and potential hepatic injury associated with these agents are given after this introductory section.

Drug Class: Antidiabetic Agents

Drugs in the Subclass Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues: Albiglutide, Dulaglutide, Exenatide, Liraglutide, Lixisenatide, Semaglutide

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999 and before the availability of exenatide or GLP-1 analogues).
De Marzio DH, Navarro VJ. Antidiabetic drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 528-30. (Review of hepatotoxicity of antidiabetic drugs mentions that there have been no published reports of hepatotoxicity of the GLP-1 analogues).
Powers AC, D'Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 863-86. (Textbook of pharmacology and therapeutics; discusses glucagon-like peptide-1 and the incretin pathway and agents that act on this pathway).
Heine RJ, Van Gaal LF, Johns D, Mihm MJ, Widel MH, Brodows RG; GWAA Study Group. Exenatide versus insulin glargine in patients with suboptimally controlled type 2 diabetes: a randomized trial. Ann Intern Med 2005; 143: 559-69. (Controlled trial of 26 weeks of exenatide vs insulin in 551 patients with poorly controlled diabetes; overall efficacy was similar, but nausea, vomiting and diarrhea were more common with exenatide; no mention of ALT elevations or hepatotoxicity). 16230722
Amori RE, Lau J, Pittas AG. Efficacy and safety of incretin therapy in type 2 diabetes: systematic review and meta-analysis. JAMA 2007; 298: 194-206. (Systematic review of 29 controlled trials of incretin-based therapies of diabetes [exenatide, liraglutide, sitagliptin and vildagliptin], concluding that they have "modest efficacy", but were well tolerated with few side effects that occur more frequently than in controls; no mention of ALT levels or hepatotoxicity). 17622601
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed to incretin based agents). 18955056
Drucker DJ, Nauck MA. The incretin system: glucagon-like peptide-1 receptor agonists and dipeptidyl peptidase-4 inhibitors in type 2 diabetes. Lancet 2006; 368 (9548): 1696-705. (Review of the basis for use of GLP-1 agonists and DPP-4 inibitors in treating diabetes; no discussion of ALT elevations or hepatotoxicity). 17098089
Drucker DJ, Buse JB, Taylor K, Kendall DM, Trautmann M, Zhuang D, Porter L; DURATION-1 Study Group. Exenatide once weekly versus twice daily for the treatment of type 2 diabetes: a randomised, open-label, non-inferiority study. Lancet 2008; 372 (9645): 1240-50. (Controlled trial of standard exenatide given twice daily vs long acting exenatide given once weekly for 30 weeks in 295 patients with type 2 diabetes; long acting preparation gave bettern control of HgA1c levels and have equivalent safety; "No clinically significant abnormalities in...chemistry...values were reported during the study"). 18782641
Scheen AJ. Exenatide once weekly in type 2 diabetes. Lancet 2008; 372: 1197-8. (Editorial regarding study by Drucker [2008] of long acting exenatide, which is given once weekly and may have better efficacy and safety compared to standard formulation that is given twice daily). 18782642
Norris SL, Lee N, Thakurta S, Chan BK. Exenatide efficacy and safety: a systematic review. Diabet Med 2009; 26: 837-46. (Systematic review of 17 studies of exenatide; "there was no evidence of" hepatic effects across studies; postmarketing experience identified more than 30 cases of acute pancreatitis). 19719703
Norris SL, Lee N, Thakurta S, Chan BK. Exenatide efficacy and safety: a systematic review. Diabet Med 2009; 26: 837-46. (Systematic review of 17 studies of exenatide; "there was no evidence of" hepatic effects across studies; postmarketing experience identified more than 30 cases of acute pancreatitis). 19719703
Blonde L, Russell-Jones D. The safety and efficacy of liraglutide with or without oral antidiabetic drug therapy in type 2 diabetes: an overview of the LEAD 1-5 studies. Diabetes Obes Metab 2009; 11 Suppl 3: 26-34. (Summary of 6 controlled trials of liraglutide, alone or with other antidiabetic agents in more than 4000 patients; most common side effects were gastrointestinal, particularly nausea; serious adverse events were no more common than with comparator arms; no mention of ALT elevations or hepatotoxicity). 19878259
Lovshin JA, Drucker DJ. Incretin-based therapies for type 2 diabetes mellitus. Nat Rev Endocrinol 2009; 5: 262-9. (Review of mechanism of action, pharmacology, clinical efficacy and safety of incretin-based therapies of diabetes; both exenatide and liraglutide are associated with weight loss and side effects of nausea and diarrhea; no mention of hepatotoxicity or ALT elevations). 19444259
Rosenstock J, Reusch J, Bush M, Yang F, Stewart M; Albiglutide Study Group. Potential of albiglutide, a long-acting GLP-1 receptor agonist, in type 2 diabetes: a randomized controlled trial exploring weekly, biweekly, and monthly dosing. Diabetes Care 2009; 32: 1880-6. (Among 356 patients with diabetes treated with albiglutide given weekly, biweekly or monthly or with placebo or twice daily exenatide for 16 weeks, side effects were dose related and included nausea, diarrhea, headache and injection site reactions; no mention of ALT elevations or hepatotoxicity). 19592625
Buse JB, Rosenstock J, Sesti G, Schmidt WE, Montanya E, Brett JH, Zychma M, et al.; LEAD-6 Study Group. Liraglutide once a day versus exenatide twice a day for type 2 diabetes: a 26-week randomised, parallel-group, multinational, open-label trial (LEAD-6). Lancet 2009; 374: 39-47. (Controlled trial of 16 weeks of liraglutide vs exenatide in 464 patients with type 2 diabetes; no mention of ALT levels or hepatotoxicity). 19515413
Fakhoury WK, Lereun C, Wright D. A meta-analysis of placebo-controlled clinical trials assessing the efficacy and safety of incretin-based medications in patients with type 2 diabetes. Pharmacology 2010; 86: 44-57. (Review of safety and efficacy of exenatide in 8 and liraglutide in 7 controlled trials; no mention of ALT levels or hepatotoxicity). 20616619
Russell-Jones D. The safety and tolerability of GLP-1 receptor agonists in the treatment of type-2 diabetes. Int J Clin Pract 2010; 64: 1402-14. (Discussion of the safety of exenatide and liraglutide in diabetes; no mention or discussion of ALT elevations or hepatotoxicity). 20716148
Kenny PR, Brady DE, Torres DM, Ragozzino L, Chalasani N, Harrison SA. Exenatide in the treatment of diabetic patients with non-alcoholic steatohepatitis: a case series. Am J Gastroenterol 2010; 105: 2707-9. (8 patients with diabetes and nonalcoholic steatohepatitis were treated with exenatide for 28 weeks; average weight decreased by 5%, ALT levels decreased from 69 to 45 U/L, and liver histology improved in 3 patients, but overall showed no change; no patient developed hepatotoxicity). 21131943
Pratley RE, Nauck M, Bailey T, Montanya E, Cuddihy R, Filetti S, Thomsen AB, et al.; 1860-LIRA-DPP-4 Study Group. Liraglutide versus sitagliptin for patients with type 2 diabetes who did not have adequate glycaemic control with metformin: a 26-week, randomised, parallel-group, open-label trial. Lancet 2010; 375: 1447-56. (Open label study of 26 weeks of liraglutide vs sitagliptin in 665 patients with diabetes; nausea and diarrhea were more common with liraglutide as was weight loss; no mention of ALT elevations or hepatotoxicity). 20417856
Ayoub WA, Kumar AA, Naguib HS, Taylor HC. Exenatide-induced acute pancreatitis. Endocr Pract 2010; 16: 80-3. (64 year old woman developed abdominal pain soon after starting exenatide leading to its discontinuation after 3 weeks, followed by hospitalization with pancreatitis at 4 weeks [amylase 131 U/L, lipase 2700 U/L, normal liver tests, CT showing a swollen pancreas, but no gallstones], resolving within 2 weeks). 19703814
Thong KY, Jose B, Sukumar N, Cull ML, Mills AP, Sathyapalan T, Shafiq W, et al.; on behalf of the ABCD nationwide exenatide audit contributors. Safety, efficacy and tolerability of exenatide in combination with insulin in the Association of British Clinical Diabetologists nationwide exenatide audit(*). Diabetes Obes Metab 2011; 13: 703-10. (Survey of exenatide use in the UK comparing patients with and without concurrent insulin treatment; insulin treated patients had more side effects, hypoglycemia and discontinuations; no mention of ALT elevations or clinically apparent liver injury). 21410858
Garber A, Henry RR, Ratner R, Hale P, Chang CT, Bode B; LEAD-3 (Mono) Study Group. Liraglutide, a once-daily human glucagon-like peptide 1 analogue, provides sustained improvements in glycaemic control and weight for 2 years as monotherapy compared with glimepiride in patients with type 2 diabetes. Diabetes Obes Metab 2011; 13: 348-56. (One year open label extension of controlled trial of liraglutide vs glimepiride in 927 patients with diabetes; diarrhea and nausea were more common with liraglutide; no mention of ALT elevations or liver injury). 21205128
Meier JJ. GLP-1 receptor agonists for individualized treatment of type 2 diabetes mellitus. Nat Rev Endocrinol 2012; 8: 728-42. (Review of the structure, mechanism of action, efficacy and safety of the GLP-1 analogues with focus on development of long acting formulations including exenatide-LAR, liraglutide, albiglutide and dulaglutide; no mention of ALT elevations or hepatotoxicity). 22945360
Fonseca VA, Alvarado-Ruiz R, Raccah D, Boka G, Miossec P, Gerich JE; EFC6018 GetGoal-Mono Study Investigators. Efficacy and safety of the once-daily GLP-1 receptor agonist lixisenatide in monotherapy: a randomized, double-blind, placebo-controlled trial in patients with type 2 diabetes (GetGoal-Mono). Diabetes Care 2012; 35: 1225-31. (Among 361 patients with previously untreated diabetes, HbA1c responses were more frequent with a 12 week course of lixisenatide vs placebo and adverse events more frequent with lixisenatide were nausea and vomiting; no mention of ALT elevations or hepatotoxicity). 22432104
Ahrén B, Leguizamo Dimas A, Miossec P, Saubadu S, Aronson R. Efficacy and safety of lixisenatide once-daily morning or evening injections in type 2 diabetes inadequately controlled on metformin (GetGoal-M). Diabetes Care 2013; 36: 2543-50. (Among 680 patients with inadequately controlled diabetes treated with lixisenatide or placebo injections once daily, morning or evening, for 24 weeks, glycemic control was improved with lixisenatide and more frequent adverse events included hypoglycemia [2.4% and 5.1% vs 0.6%], nausea [23% and 22% vs 8%] and vomiting [9% and 13% vs e%]; no mention of ALT elevations or hepatotoxicity). 23536584
Elkinson S, Keating GM. Lixisenatide: first global approval. Drugs 2013; 73: 383-91. (Review of the history of development, pharmacology, clinical efficacy, and adverse events of lixisenatide focusing upon hypoglycemia and lixisenatide antibodies; no mention of ALT elevations or hepatotoxicity). 23558600
Pinget M, Goldenberg R, Niemoeller E, Muehlen-Bartmer I, Guo H, Aronson R. Efficacy and safety of lixisenatide once daily versus placebo in type 2 diabetes insufficiently controlled on pioglitazone (GetGoal-P). Diabetes Obes Metab 2013; 15: 1000-7. (Among 484 patients with diabetes inadequately controlled by pioglitazone who were treated with lixisenatide or placebo injections for 24 weeks, glycemic control was improved by addition of lixisenatide and adverse events including nausea, vomiting, allergic reactions; no mention of ALT elevations or hepatotoxicity). 23627775
Rosenstock J, Raccah D, Korányi L, Maffei L, Boka G, Miossec P, Gerich JE. Efficacy and safety of lixisenatide once daily versus exenatide twice daily in type 2 diabetes inadequately controlled on metformin: a 24-week, randomized, open-label, active-controlled study (GetGoal-X). Diabetes Care 2013; 36: 2945-51. (Among 336 patients with diabetes inadequately controlled on metformin who were treated with lixisenatide or exenatide for 24 weeks, HbA1c improved similarly in both groups and overall and serious adverse event rates were similar, and “no clinically relevant changes” in ALT or AST occurred in either group). 23698396
Armstrong MJ, Houlihan DD, Rowe IA, Clausen WH, Elbrønd B, Gough SC, Tomlinson JW, et al. Safety and efficacy of liraglutide in patients with type 2 diabetes and elevated liver enzymes: individual patient data meta-analysis of the LEAD program. Aliment Pharmacol Ther 2013; 37: 234-42. (Among 442 patients with diabetes treated in 6 trials of 24-weeks of liraglutide vs placebo, 2241 [51%] had abnormal ALT levels at baseline, among whom ALT levels decreased more with liraglutide [-8 U/L] than placebo [-5 U/L], but the effect was not seen after adjusting for differences in weight loss). 23163663
Pratley RE, Nauck MA, Barnett AH, Feinglos MN, Ovalle F, Harman-Boehm I, et al.; HARMONY 7 study group. Once-weekly albiglutide versus once-daily liraglutide in patients with type 2 diabetes inadequately controlled on oral drugs (HARMONY 7): a randomised, open-label, multicentre, non-inferiority phase 3 study. Lancet Diabetes Endocrinol 2014; 2: 289-97. (Among 841 adults with inadequately controlled diabetes treated with injections of albiglutide [weekly] or liraglutide [daily] for 32 weeks, HbA1c levels decreased in both groups and adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 24703047
Bolli GB, Munteanu M, Dotsenko S, Niemoeller E, Boka G, Wu Y, Hanefeld M. Efficacy and safety of lixisenatide once daily vs. placebo in people with Type 2 diabetes insufficiently controlled on metformin (GetGoal-F1). Diabet Med 2014; 31: 176-84. (Among 484 patients with diabetes inadequately controlled on metformin who were treated with lixisenatide or placebo once daily for at least 52 weeks, glycemic control was greater with lixisenatide therapy and side effects associated with it included nausea and vomiting, hypoglycemia and allergic reactions, while “analysis of safety laboratory… data did not reveal and specific safety signals”). 24117597
Gluud LL, Knop FK, Vilsbøll T. Effects of lixisenatide on elevated liver transaminases: systematic review with individual patient data meta-analysis of randomised controlled trials on patients with type 2 diabetes. BMJ Open 2014; 4: e005325. (Among 15 controlled trials of lixisenatide for which individual results were available, 1070 patients had elevated ALT levels at baseline lixisenatide had a beneficial effect in normalizing ALT levels in overweight and obese subjects, but not in those with normal weight, and no effect was found on AST, alkaline phosphatase or bilirubin levels). 25526792
Two new GLP-1 receptor agonists for diabetes. Med Lett Drugs Ther 2014; 56 (1455): 109-11. (Concise review of the mechanism of action, efficacy, side effects and costs of albiglutide and dulaglutide shortly after their approval in the US mentions that gastrointestinal effects are the most common side effects of GLP-1 analogues and that they have been rarely associated with pancreatitis; no mention of ALT elevations or hepatotoxicity). 25372847
Dungan KM, Povedano ST, Forst T, González JG, Atisso C, Sealls W, Fahrbach JL. Once-weekly dulaglutide versus once-daily liraglutide in metformin-treated patients with type 2 diabetes (AWARD-6): a randomised, open-label, phase 3, non-inferiority trial. Lancet 2014; 384 (9951): 1349-57. (Among 599 patients with diabetes poorly controlled on metformin who were treated with either dulaglutide or liraglutide for 24 weeks, efficacy and side effects were similar, common adverse events being nausea [20%], diarrhea [12%], dyspepsia [8%] ane weight loss [~3 kg]; no case of pancreatitis and no mention of ALT elevations or hepatotoxicity). 25018121
Wysham C, Blevins T, Arakaki R, Colon G, Garcia P, Atisso C, Kuhstoss D, Lakshmanan M. Efficacy and safety of dulaglutide added onto pioglitazone and metformin versus exenatide in type 2 diabetes in a randomized controlled trial (AWARD-1). Diabetes Care 2014; 37: 2159-67. (Among 976 patients with diabetes poorly controlled on metformin and pioglitazone who were treated with 1 of 2 doses of dulaglutide, exenatide or placebo for 52 weeks, common side effects of dulaglutide were nausea, vomiting, diarrhea, dyspepsia, decreased appetite and hypoglycemia; 1 patient developed pancreatitis, but no mention of ALT elevations or hepatotoxicity). 24879836
Umpierrez G, Tofé Povedano S, Pérez Manghi F, Shurzinske L, Pechtner V. Efficacy and safety of dulaglutide monotherapy versus metformin in type 2 diabetes in a randomized controlled trial (AWARD-3). Diabetes Care 2014; 37: 2168-76. (Among 807 patients with diabetes treated with dulaglutide or metformin for 52 weeks, common adverse events included nausea, vomiting, diarrhea, decreased appetite and hypoglycemia; no mention of ALT elevations or hepatotoxicity). 24842985
Nauck M, Weinstock RS, Umpierrez GE, Guerci B, Skrivanek Z, Milicevic Z. Efficacy and safety of dulaglutide versus sitagliptin after 52 weeks in type 2 diabetes in a randomized controlled trial (AWARD-5). Diabetes Care 2014; 37: 2149-58. (Among 1098 patients with diabetes treated with 2 doses of dulaglutide, sitagliptin or placebo for 1 year, common adverse events were nausea, vomiting and diarrhea; no mention of ALT elevations or hepatotoxicity). 24742660
Ahrén B, Johnson SL, Stewart M, Cirkel DT, Yang F, Perry C, Feinglos MN; HARMONY 3 Study Group. HARMONY 3: 104-week randomized, double-blind, placebo- and active-controlled trial assessing the efficacy and safety of albiglutide compared with placebo, sitagliptin, and glimepiride in patients with type 2 diabetes taking metformin. Diabetes Care 2014; 37: 2141-8. (Among 999 patients with diabetes poorly controlled on metformin who were treated with the addition of albiglutide, glimepiride, sitagliptin or placebo for 2 years, common side effects included injection site reactions, diarrhea, nausea and 2 of 302 albiglutide treated patients developed pancreatitis; no mention of ALT elevations or hepatotoxicity). 24898304
Reusch J, Stewart MW, Perkins CM, Cirkel DT, Ye J, Perry CR, Reinhardt RR, et al. Efficacy and safety of once-weekly glucagon-like peptide 1 receptor agonist albiglutide (HARMONY 1 trial): 52-week primary endpoint results from a randomized, double-blind, placebo-controlled trial in patients with type 2 diabetes mellitus not controlled on pioglitazone, with or without metformin. Diabetes Obes Metab 2014; 16: 1257-64. (Among 310 patients with diabetes on pioglitazone with or without metformin who were treated albiglutide or placebo injected weekly for up to 3 years, overall rates of side effects were similar in both groups [diarrhea in 9% vs 11%] and no patient developed pancreatitis; no mention of ALT elevations or hepatotoxicity). 25155146
Kern E, VanWagner LB, Yang GY, Rinella ME. Liraglutide-induced autoimmune hepatitis. JAMA Intern Med 2014; 174: 984-7. (A woman of unstated age developed jaundice 4 months after starting liraglutide for type 2 diabetes [bilirubin 9.5 mg/dL, ALT 1123 U/L, Alk P not given, INR 1.3, ANA negative] and subsequently worsened despite stopping liraglutide, biopsy showing submassive necrosis and responding to corticosteroid therapy which was required long term). 24733687
Weissman PN, Carr MC, Ye J, Cirkel DT, Stewart M, Perry C, Pratley R. HARMONY 4: randomised clinical trial comparing once-weekly albiglutide and insulin glargine in patients with type 2 diabetes inadequately controlled with metformin with or without sulfonylurea. Diabetologia 2014; 57: 2475-84. (Among 779 patients with diabetes inadequately controlled on metformin who were treated with injections of albiglutide weekly or insulin daily for one year, gastrointestinal side effects were more common with albiglutide, but hypoglycemia and weight gain were less common while no patient developed pancreatitis; no mention of ALT elevations or hepatotoxicity). 25208756
Thompson AM, Trujillo JM. Dulaglutide: the newest GLP-1 receptor agonist for the management of type 2 diabetes. Ann Pharmacother 2015; 49: 351-359. (Review of the pharmacology, mechanism of action, efficacy and safety of dulaglutide, the most common side effects are gastointestinal symptoms; pancreatitis occurs, but is rare; no mention of ALT elevations or hepatotoxicity). 25565404
Pfeffer MA, Claggett B, Diaz R, Dickstein K, Gerstein HC, Køber LV, Lawson FC, et al.; ELIXA Investigators. Lixisenatide in patients with type 2 diabetes and acute coronary syndrome. N Engl J Med 2015; 373: 2247-57. . (Among 6068 patients with diabetes and a history of a recent acute coronary syndrome who were treated with lixisenatide vs placebo added to standard diabetes care, subsequent cardiovascular endpoints occurred in a similar proportion of both groups [13.4% vs 13.2%] and adverse event rates were similar for hyperglycemia, pancreatitis and hepatobiliary events, but lixisenatide treated subjects had higher rates of nausea and vomiting resulting in drug discontinuation [3% vs 0.4%]). 26630143
Wysham CH, MacConell LA, Maggs DG, Zhou M, Griffin PS, Trautmann ME. Five-year efficacy and safety data of exenatide once weekly: long-term results from the DURATION-1 randomized clinical trial. Mayo Clin Proc 2015; 90: 356-65. (Among 258 diabetic patients enrolled in a 5 year extension study of weekly exenatide therapy, beneficial effects on HbA1c and glucose levels were maintained and “liver function changes from baseline … were minimal”, ALT levels decreasing by 4.4 U/L; no mention of episodes of clinically apparent liver injury). 25744115
Weinstock RS, Guerci B, Umpierrez G, Nauck MA, Skrivanek Z, Milicevic Z. Safety and efficacy of once-weekly dulaglutide versus sitagliptin after 2 years in metformin-treated patients with type 2 diabetes (AWARD-5): a randomized, phase III study. Diabetes Obes Metab 2015; 17: 849-58. (Among 1098 patients with diabetes treated with dulaglutide or sitagliptin for up to 2 years, decreases in HgA1c levels were greater with dulaglutide as were gastrointestinal adverse events such as nausea, vomiting and diarrhea, but no mention of ALT elevations or hepatotoxicity). 25912221
Dungan KM, Weitgasser R, Perez Manghi F, Pintilei E, Fahrbach JL, Jiang HH, Shell J, et al. A 24-week study to evaluate the efficacy and safety of once-weekly dulaglutide added on to glimepiride in type 2 diabetes (AWARD-8). Diabetes Obes Metab 2016; 18: 475-82. (Among 300 patients with diabetes being treated with glimepiride to which was added once weekly injections of dulaglutide vs placebo for 24 weeks, decreases in HgA1c levels were greater with dulaglutide and adverse events included nausea [10% vs 0] and diarrhea [8% vs 0]; no mention of ALT elevations or hepatotoxicity). 26799540
Armstrong MJ, Gaunt P, Aithal GP, Barton D, Hull D, Parker R, Hazlehurst JM, et al. Liraglutide safety and efficacy in patients with non-alcoholic steatohepatitis (LEAN): a multicentre, double-blind, randomised, placebo-controlled phase 2 study. Lancet 2016; 387 (10019): 679-90. (Among 52 patients with nonalcoholic steatohepatitis [NASH] treated with daily injections of liraglutide [1.8 mg] or placebo for 48 weeks, ALT levels and histological features of injury improved more with liraglutide as did weight loss [5.3 vs 0.6 kg], and there were no cases of pancreatitis or worsening of liver disease). 26608256
Seko Y, Sumida Y, Tanaka S, Mori K, Taketani H, Ishiba H, Hara T, et al. Effect of 12-week dulaglutide therapy in Japanese patients with biopsy-proven non-alcoholic fatty liver disease and type 2 diabetes mellitus. Hepatol Res 2016 Nov 2. [Epub ahead of print]. (Among 15 Japanese patients with NASH treated with dulaglutide [0.75 mg weekly] for 12 weeks, ALT levels decreased, histological features of injury improved, and there were no serious adverse events). 27917557
Nauck M, Rizzo M, Johnson A, Bosch-Traberg H, Madsen J, Cariou B. Once-daily liraglutide versus lixisenatide as add-on to metformin in type 2 diabetes: a 26-week randomized controlled clinical trial. Diabetes Care 2016; 39: 1501-9. (Among 404 patients with diabetes inadequately controlled on metformin enrolled in a controlled trial for 26 weeks, glycemic control was better, but adverse event rates were higher with once-daily liraglutide than lixisenatide; no mention of ALT elevations or hepatotoxicity). 27311491
Marso SP, Daniels GH, Brown-Frandsen K, Kristensen P, Mann JF, Nauck MA, Nissen SE, et al.; LEADER Steering Committee.; LEADER Trial Investigators. Liraglutide and cardiovascular outcomes in type 2 diabetes. N Engl J Med 2016; 375: 311-22. (Among 9340 patients with diabetes at high risk of cardiovascular complications treated with liraglutide [1.8 mg] or placebo injections daily for a median of 3.8 years, cardiovascular deaths were lower with liraglutide than placebo [4.7% vs 6%], but rates of nonfatal endpoints were no different and adverse events associated with liraglutide included weight loss, acute gallstone disease [3.1% vs 1.9%], injection site reactions, nausea [1.6% vs 0.4%], vomiting, diarrhea, and abdominal pain; no mention of ALT elevations or hepatotoxicity). 27295427
Mehta A, Marso SP, Neeland IJ. Liraglutide for weight management: a critical review of the evidence. Obes Sci Pract 2017; 3: 3-14. (Review of 5 placebo controlled trials of liraglutide for weight loss mentions a 4 to 6 kg greater loss with liraglutide vs placebo with common adverse events of nausea, diarrhea, vomiting, headache, fatigue, dizziness, abdominal pain and increased lipase; no discussion of ALT elevations or hepatotoxicity, but mentions that liraglutide should be used cautiously in patients with impaired liver function). 28392927
Pratley RE, Aroda VR, Lingvay I, Lüdemann J, Andreassen C, Navarria A, Viljoen A; SUSTAIN 7 investigators. Semaglutide versus dulaglutide once weekly in patients with type 2 diabetes (SUSTAIN 7): a randomised, open-label, phase 3b trial. Lancet Diabetes Endocrinol 2018; 6: 275-86. (Among 1201 patients with type 2 diabetes and inadequate glycemic control on metformin treated with semaglutide or dulaglutide sc once weekly for 40 weeks, semaglutide led to greater improvements in glycemic control while adverse even rates were similar; no mention of ALT elevations or hepatotoxicity). 29397376
Semaglutide (Ozempic)--another injectable GLP-1 receptor agonist for type 2 diabetes. Med Lett Drugs Ther 2018; 60 (1539): 19-21. (Concise review of the mechanism of action, clinical efficacy, safety and costs of semaglutide shortly after its approval in the US; mentions common adverse events of nausea, vomiting, diarrhea, constipation and abdominal pain as well as skin hypersensitivity reactions, but does not mention ALT elevations or hepatotoxicity). 29364197
Lixisenatide for type 2 diabetes. Med Lett Drugs Ther 2017; 59 (1513): 19-21. (Concise review of the mechanism of action, clinical efficacy, safety and costs of lixisenatide shortly after its approval in the US; mentions the uncommon side effects of anaphylaxis [0.1%], renal insufficiency and pancreatitis, but no mention of ALT elevations or hepatotoxicity). 28118649